# Guanfacine

## OVERVIEW

### Introduction

Guanfacine is a selective alpha-adrenergic receptor agonist used for the treatment of hypertension and attention deficit hyperactivity disorder (ADHD) in adults and children. Guanfacine has not been linked to serum enzyme elevations during treatment or to cases of acute, clinically apparent liver injury.

### Background

Guanfacine (gwahn' fa seen) is a selective alpha-2A-adrenergic receptor agonist initially approved as therapy of hypertension and subsequently for management of attention deficit hyperactivity disorder (ADHD). It is currently used mostly as therapy of ADHD, both in children and adults. Therapy with extended release formulations of guanfacine have been shown to lead to improvements in levels of psychological functioning and performance in children and adolescents with suspected ADHD. Guanfacine is available in multiple formulations including tablets of 1 and 2 mg generically and under the brand name Tenex for treatment of hypertension and as extended release tablets of 1, 2, 3 and 4 mg generically and under the brand name Intuniv for the treatment of ADHD. The recommended initial dosage for hypertension in adults is 1 mg daily, with subsequent increases to a maintenance dose of up to 3 mg daily. The recommended dosage of the extended release formulation for treatment of ADHD is 1 mg daily, with subsequent increases to a maintenance dose of up to 7 mg daily. Common side effects include somnolence, sedation, headache, nausea, dizziness, bradycardia, low blood pressure, fatigue and dry mouth. Rare, but potentially severe adverse events include skin rash, bradycardia, hypotension and syncope.

### Hepatotoxicity

In the multiple clinical trials of guanfacine in adolescents and children with ADHD there were no reports of serum enzyme elevations or in instances of clinically apparent liver injury. Furthermore, despite widescale use of the agent for both hypertension and ADHD, there have been no reports of clinically apparent liver injury attributable to guanfacine. Thus, significant liver injury from guanfacine must be quite rare, if it exists at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which guanfacine might cause liver injury is unknown. Guanfacine is metabolized in the liver by the cytochrome P450 system, predominantly CYP 3A4 and production of a toxic intermediate or immunogenic byproduct are reasonable explanations. Guanfacine is susceptible to drug-drug interactions with agents that modulate CYP 3A4 activity, inhibitors causing an increase and inducers causing a decrease in guanfacine plasma levels. The hepatic safety of guanfacine may relate to the low total daily doses used (1 to 7 mg daily).

Drug Class: Antihypertensive Agents, ADHD Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Guanfacine – Generic, Tenex®, Intuniv®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Guanfacine&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Guanfacine | 29110-47-2 | C9-H9-Cl2-N3-O

## ANNOTATED BIBLIOGRAPHY

References updated: 25 August 2021

Abbreviations: ADHD, attention deficit/hyperactivity disorder.

Zimmerman HJ. Psychotropic and anticonvulsant agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-516. (Expert review of hepatotoxicity published in 1999; guanfacine is not mentioned).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychotropic drugs; guanfacine is not discussed).
O'Donnell JM, Bies RR, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Halil-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
Jerie P. (1986). Long-term evaluations of therapeutic efficacy and safety of guanfacine. Am J Cardiol. (Among 580 adults with hypertension treated with guanfacine for up to two years, blood pressure normalized in 54-66% of patients and “no…biochemical alterations that could be attributed to guanfacine occurred”).
Scahill L, Chappell PB, Kim YS, Schultz RT, Katsovich L, Shepherd E, Arnsten AF, et al. (2001). A placebo-controlled study of guanfacine in the treatment of children with tic disorders and attention deficit hyperactivity disorder. Am J Psychiatry. (Among 34 children with ADHD and tic disorders treated with guanfacine or placebo for 8 weeks, ADHD scores improved more with guanfacine and no serious side effects or “alterations in laboratory test results” occurred).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al., Drug Induced Liver Injury Network(DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to guanfacine).
Biederman J, Melmed RD, Patel A, McBurnett K, Konow J, Lyne A, Scherer N, SPD503 Study Group. (2008). A randomized, double-blind, placebo-controlled study of guanfacine extended release in children and adolescents with attention-deficit/hyperactivity disorder. Pediatrics. (Among 345 children and adolescents with ADHD treated with guanfacine [2, 3 or 4 mg daily] or placebo for 8 weeks, ADHD scores improved more in guanfacine treated subjects and common adverse events included sedation, somnolence, dizziness, fatigue, nausea, drug mouth and abdominal pain; no mention of ALT levels or hepatotoxicity).
Sallee FR, Lyne A, Wigal T, McGough JJ. (2009). Long-term safety and efficacy of guanfacine extended release in children and adolescents with attention-deficit/hyperactivity disorder. J Child Adolesc Psychopharmacol. (Among 259 children with ADHD treated with guanfacine at varying doses for up to 24 months, the most common adverse events were somnolence and headache; no mention of ALT elevations or hepatotoxicity).
Sallee FR, McGough J, Wigal T, Donahue J, Lyne A, Biederman J, SPD503 STUDY GROUP. (2009). Guanfacine extended release in children and adolescents with attention-deficit/hyperactivity disorder: a placebo-controlled trial. J Am Acad Child Adolesc Psychiatry. (Among 321 children [ages 6-17] with ADHD treated with guanfacine [1, 2, 3 or 4 mg daily] or placebo for 9 weeks, improvements in ADHD rating scores were greater with guanfacine while side effects of somnolence, headache and fatigue were more frequent, although “no clinically meaningful changes in laboratory assessments were observed for any of the study subjects”).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, with 2 agents used for ADHD among the top 41 causes; methylphenidate [11th, 96 cases] and atomoxetine [14th, 64 cases]; guanfacine was not mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury; psychotropic agents accounted for 4 cases, including quetiapine, nefazodone, fluoxetine and venlafaxine, but none were attributed to guanfacine).
Connor DF, Findling RL, Kollins SH, Sallee F, López FA, Lyne A, Tremblay G. (2010). Effects of guanfacine extended release on oppositional symptoms in children aged 6-12 years with attention-deficit hyperactivity disorder and oppositional symptoms: a randomized, double-blind, placebo-controlled trial. CNS Drugs. (Among 217 children with ADHD treated with guanfacine or placebo for 9 weeks, adverse events that were more frequent with guanfacine included somnolence [51% vs 5%], headache [22% vs 18%], sedation [13% vs 1%], abdominal pain [12% vs 3%] and fatigue [11% vs 5%]; no mention of laboratory study results).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, 3 were attributed to atomoxetine and one to methylphenidate, but none to guanfacine).
Wilens TE, Bukstein O, Brams M, Cutler AJ, Childress A, Rugino T, Lyne A, et al. (2012). A controlled trial of extended-release guanfacine and psychostimulants for attention-deficit/hyperactivity disorder. J Am Acad Child Adolesc Psychiatry. (Among 461 children or adolescents with ADHD with suboptimal response to psychostimulants, those treated with guanfacine had greater improvements in ADHD rating scores than placebo controls, and there were no treatment related serious adverse events and no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, but none were attributed to guanfacine or other drugs used to treat ADHD).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to guanfacine or other ADHD agents).
Hervas A, Huss M, Johnson M, McNicholas F, van Stralen J, Sreckovic S, Lyne A, et al. (2014). Efficacy and safety of extended-release guanfacine hydrochloride in children and adolescents with attention-deficit/hyperactivity disorder: a randomized, controlled, phase III trial. Eur Neuropsychopharmacol. (Among 272 children or adolescents with ADHD treated for 4-7 weeks, improvements in ADHD rating scores were greater for guanfacine than atomoxetine and placebo as were adverse event rates, including somnolence, headache and fatigue, which were rarely severe; no mention of ALT elevations or hepatotoxicity).
Wilens TE, Robertson B, Sikirica V, Harper L, Young JL, Bloomfield R, Lyne A, et al. (2015). A randomized, placebo-controlled trial of guanfacine extended release in adolescents with attention-deficit/ hyperactivity disorder. J Am Acad Child Adolesc Psychiatry. (Among 314 adolescents with ADHD treated with guanfacine or placebo for 13 weeks, improvements in ADHD rating scores were greater for guanfacine and adverse events included somnolence [44% vs 21%], headache [27% v 18%] and fatigue [22% vs 12%], and “there were no clinically meaningful differences” in “clinical chemistry … analyses”).
Drugs for ADHD. (2015). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs approved for use in ADHD; mentions that an extended release form of guanfacine has been approved for use in ADHD and mentions adverse reactions of somnolence, bradycardia, hypotension and syncope, but does not mention ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 [0.5%] were attributed to atomoxetine but none to guanfacine).
Butterfield ME, Saal J, Young B, Young JL. (2016). Supplementary guanfacine hydrochloride as a treatment of attention deficit hyperactivity disorder in adults: A double blind, placebo-controlled study. Psychiatry Res. (Among 26 adults with ADHD and a suboptimal response to conventional stimulants treated with guanfacine [1 to 6 mg] or placebo daily for 10 weeks, improvements in ADHD rating scores were similar in all groups as were adverse event rates; no mention of ALT elevations or hepatotoxicity and no patient stopped therapy for side effects).
Padilha SCOS, Virtuoso S, Tonin FS, Borba HHL, Pontarolo R. (2018). Efficacy and safety of drugs for attention deficit hyperactivity disorder in children and adolescents: a network meta-analysis. Eur Child Adolesc Psychiatry. (Systematic review of efficacy and safety of drugs for ADHD based upon 48 trials [4169 participants]; makes no mention of ALT elevations or hepatotoxicity of any of the agents studied, including guanfacine).
Cortese S, Adamo N, Mohr-Jensen C, Hayes AJ, Bhatti S, Carucci S, Del Giovane C, et al., European ADHD Guidelines Group (EAGG). (2017). Comparative efficacy and tolerability of pharmacological interventions for attention-deficit/hyperactivity disorder in children, adolescents and adults: protocol for a systematic review and network meta-analysis. BMJ Open. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Huss M, Dirks B, Gu J, Robertson B, Newcorn JH, Ramos-Quiroga JA. (2018). Long-term safety and efficacy of guanfacine extended release in children and adolescents with ADHD. Eur Child Adolesc Psychiatry. (Among 215 children and adolescents with ADHD treated with dose-optimized guanfacine [1-7 mg/day] for up to 2 years, common adverse events were somnolence [36%], headache [29%], fatigue [20%] and dizziness [9%], most being transient, mild-to-moderate occurring early during dosing; there were no deaths and no serious hepatic adverse events or discontinuations for liver injury or ALT elevations).
Schoretsanitis G, de Leon J, Eap CB, Kane JM, Paulzen M. (2019). Clinically significant drug-drug interactions with agents for attention-deficit/hyperactivity disorder. CNS Drugs. (Review of drug-drug interactions of agents used to treat ADHD mentions that guanfacine is metabolized largely by CYP 3A4 and levels are reduced by CYP 3A4 inducers [rifampin, phenobarbital] requiring dose increases [doubling], and are increased by CYP 3A4 inhibitors [ketoconazole] theoretically requiring halving of the dosage).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of mechanism of action, clinical efficacy, safety and cots of drugs for ADHD mentions that guanfacine is a nonstimulatory agent that is generally well tolerated; no mention of ALT elevations or hepatotoxicity).
Iwanami A, Saito K, Fujiwara M, Okutsu D, Ichikawa H. Efficacy and safety of guanfacine extended-release in the treatment of attention-deficit/hyperactivity disorder in adults: Results of a randomized, double-blind, placebo-controlled study. J Clin Psychiatry. 2020;81:19m12979. (Among 201 Japanese adults with ADHD treated with guanfacine or placebo for 10 weeks, ADHD rating scales improved more with guanfacine than placebo [-11.6 vs -7.3]; while adverse events were more frequent [81% vs 62%], they were usually mild-to-moderate and there were no deaths and no serious hepatic adverse events).
Iwanami A, Saito K, Fujiwara M, Okutsu D, Ichikawa H. (2020). Safety and efficacy of guanfacine extended-release in adults with attention-deficit/hyperactivity disorder: an open-label, long-term, phase 3 extension study. BMC Psychiatry. (Among 150 Japanese adults with ADHD enrolled in a 50 week open label extension study of guanfacine [maintenance dose 4-6 mg daily], there were no deaths, no serious hepatic adverse events, and “no clinically relevant changes in … clinical laboratory tests”).

## OTHER REFERENCE LINKS

1 Recent References on Guanfacine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Guanfacine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Guanfacine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Guanfacine)